# Fitusiran

## OVERVIEW

### Introduction

Fitusiran is a synthetic small interfering RNA (siRNA) molecule directed against antithrombin that is used as prophylaxis against bleeding episodes in patients with hemophilia A or B. Fitusiran has been linked to mild-to-moderate ALT elevations during therapy and to rare cases of acute liver injury with jaundice. It has also been associated with cholelithiasis and cholecystitis.

### Background

Fitusiran (fit” ue sir’ an) is a synthetic, double-stranded, small interfering RNA (siRNA) directed against antithrombin, which results in an increase in coagulability and decrease in bleeding episodes in patients with hemophilia. The two major forms of hemophilia, hemophilia A and B, are genetic X-linked disorders due to deficiency in coagulation factors VIII (hemophilia A) or IX (hemophilia B). Both forms of hemophilia are rare, hemophilia A occurring in approximately 1:5,000 and hemophilia B in 1:25,000 live male births. Both disorders are characterized by frequent episodes of bleeding occurring spontaneously or with minor trauma that can result in disability and early mortality. The current standard therapy of hemophilia A and B is use of intravenous factor VIII or IX infusions for acute bleeding episodes and prophylactic replacement therapy using infusions every 1 to 2 weeks. However, despite coagulation factor prophylaxis, bleeding episodes still occur particularly in patients who develop neutralizing antibodies (inhibitors). Fitusiran reduces bleeding episodes by inhibition of antithrombin, a liver produced protein which acts as a natural anticoagulant, terminating the coagulation cascade induced by thrombin. Fitusiran is a double-stranded RNA conjugated with N-acetyl-galactosamine which is taken up by the asialoglycoprotein receptor found only on hepatocytes. Within hepatocytes, the double-stranded siRNA is cleaved into smaller fragments and separated into single strands that bind and silence the mRNA of antithrombin. In animal models of hemophilia, fitusiran reduced antithrombin levels and improved hemostasis. In placebo-controlled trials of fitusiran in patients with hemophilia A or B with and without inhibitors, single injections of fitusiran resulted in dose related reductions in antithrombin. With monthly or every other month dosing, the annualized rates of bleeding episodes decreased by an average of 70% and a proportion of patients had no bleeding episodes. Fitusiran was approved for use in the United States for patients with hemophilia A or B with or without inhibitors in 2025. Current indications are limited to adults and children 12 years of age or older. Fitusiran is available in solution in single-dose pre-filled pens of 50 mg (in 0.5 mL) and in single dose vials of 20 mg (in 0.2 mL) under the brand name Qfitlia. The recommended initial dose regimen is 50 mg subcutaneously once every 2 months with monitoring of antithrombin levels and dose adjustment to maintain antithrombin levels at 15%-35% of normal. Fitusiran is generally well tolerated with few side effects attributable to the drug, the product label listing only viral and bacterial infections. Less common, but more severe side effects include thrombotic events and acute and recurrent gallbladder disease and its complications which can lead to cholecystectomy.

### Hepatotoxicity

Hemophilia A and B are rare, and the pivotal trials of fitusiran were conducted in rather small numbers of patients for limited periods of time, so the full spectrum of hepatotoxicity may not be fully known. Nevertheless, in the registration-controlled trials using the highest doses of fitusiran [80 mg every month], serum aminotransferase elevations arose above 3 times the upper limit of normal (ULN) in 17% to 32% of treated patients versus none of the controls. Levels above 5 times ULN were rare, but one patient developed elevations with jaundice and required discontinuation which resulted in prompt resolution. This high rate of ALT elevations was not seen with the currently recommended lower dose regimen. Using an initial dose of 50 mg every two months followed by dose adjustments to maintain antithrombin levels of 15% to 35%, ALT elevations above 3 times ULN arose in only 3.4% of patients, and there were no instances of clinically apparent liver injury or jaundice with ALT elevations. Since approval of fitusiran, there have been no reports of drug-induced liver injury, but its clinical use has been limited. Thus, fitusiran appears to be capable of causing clinically apparent acute liver injury, but the frequency, clinical features, and severity of such episodes have not been defined.

The increased risk for gallbladder disease associated with fitusiran therapy is not well understood, but 17% of patients treated with the 80 mg dose given monthly vs none of the controls developed symptomatic cholecystitis, cholangitis, or choledocholithiasis. Some patients developed pancreatitis, and a proportion required cholecystectomy. Again, this adverse event was less frequent in patients receiving the currently recommended regimen of 50 mg every two months with dose adjustments, occurring in only 4% of patients, only one of whom required cholecystectomy. Patients with acute cholecystitis or cholangitis can have accompanying elevations in liver tests. For this reason, it is important to rule out gallbladder disease as a cause when elevations in liver associated enzymes are found.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatic injury and gallbladder disorders from the fitusiran is unknown. Fitusiran is metabolized endo- and exo-nucleases and is not a substrate of cytochrome P450 enzymes. Serum aminotransferase elevations rarely occur with other siRNA therapeutic agents. One possibility is that the suppression of antithrombin activity may result in hepatocellular injury by an unknown mechanism or that the mRNA suppression may not be completely specific for antithrombin and effect synthesis of other essential proteins.

### Outcome and Management

The liver injury associated with fitusiran therapy has been mild, rarely associated with jaundice or symptoms, and rapidly resolving with discontinuation or even dose adjustment. In prelicensure clinical trials, patients were followed carefully for evidence of liver injury and current recommendations are that liver tests be monitored regularly, at least monthly for six months after the initial dose or after any dose increase, and as clinically indicated thereafter. Temporary interruption or discontinuation is recommended for significant and persistent serum aminotransferase elevations or any elevations with jaundice or symptoms.

Drug Class: Genetic Disorder Agents

Other Therapeutic siRNA Agents: Givosiran, Patisiran, Golodirsen, Eteplirsen

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fitusiran – Qfitlia®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fitusiran)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Fitusiran | 1499251-18-1 | C88-H151-N16-O37-P (https://pubchem.ncbi.nlm.nih.gov/#query=C88H151N16O37P)

## ANNOTATED BIBLIOGRAPHY

References updated: 25 July 2025

Abbreviations: siRNA, small interfering RNA.

FDA. Fitusiran. Multi-Disciplinary Review and Evaluation. 2025. Available at: https://www.accessdata.fda.gov/drugsatfda_docs/nda/2025/219019Orig1s000IntegratedR.pdf (The FDA integrated review of fitusiran for efficacy and safety reported ALT elevations above 3 times ULN arose in 32% of hemophilia patients with inhibitors and 17% of those without inhibitors who received fitusiran in a dose of 80 mg once every other month compared to none of the controls receiving on-demand coagulation factor replacement therapy, but that lower rates of ALT elevations [only 3.4%] arose in an open-label follow up study using the currently recommended dose regimen of fitusiran; one patient receiving the high dose regimen developed clinically apparent liver injury with jaundice, that resolved rapidly with drug discontinuation).
Pasi KJ, Rangarajan S, Georgiev P, Mant T, Creagh MD, Lissitchkov T, Bevan D, et al. Targeting of antithrombin in hemophilia A or B with RNAi therapy. N Engl J Med. 2017;377:819-828. PMID:. (Description of pre-clinical and early clinical studies of fitusiran therapy of hemophilia A and B with fitusiran, an siRNA that targets antithrombin which partially corrects the coagulopathy of hemophilia by stabilizing and inducing thrombin generation). 28691885
Machin N, Ragni MV. An investigational RNAi therapeutic targeting antithrombin for the treatment of hemophilia A and B. J Blood Med. 2018;9:135-140.. (Review of the mechanism of therapeutics based upon RNA inhibition and the design of a bypassing siRNA approach to prevention of bleeding episodes in patients with hemophilia that would be effective for both hemophilia A and B and for patients with and without inhibitors). 30174468
Setten RL, Rossi JJ, Han SP. The current state and future directions of RNAi-based therapeutics. Nat Rev Drug Discov 2019; 18: 421-46. (Extensive review of gene silencing using RNA interference pathways and the potential of RNAi therapeutics which have promise in many genetic and acquired diseases including transthyretin amyloidosis [transthyretin], HIV infection [CCR5], HBV [HBV mRNA], alpha-1-antitrypsin deficiency [zz A1AT], hypercholesterolemia [PCSK9]). 30846871
Young G, Srivastava A, Kavakli K, Ross C, Sathar J, You CW, Tran H, et al. Efficacy and safety of fitusiran prophylaxis in people with haemophilia A or haemophilia B with inhibitors (ATLAS-INH): a multicentre, open-label, randomised phase 3 trial. Lancet. 2023;401(10386):1427-1437.. (Among 57 men with severe hemophilia A or B with inhibitors were treated with fitusiran [80 mg] sc once monthly or continued on-demand therapies for 9 months, the median annualized rate of bleeding was lower with fitusiran [1.7 vs 18.1] and the most frequent adverse event was ALT elevations [32% versus none]). 37003287
Srivastava A, Rangarajan S, Kavakli K, Klamroth R, Kenet G, Khoo L, You CW, et al. Fitusiran prophylaxis in people with severe haemophilia A or haemophilia B without inhibitors (ATLAS-A/B): a multicentre, open-label, randomised, phase 3 trial. Lancet Haematol. 2023;10:e322-e332.. (Among 120 males, ages 12 or older, with severe hemophilia A or B without inhibitors treated with fitusiran [80 mg sc once monthly] or continued on-demand clotting factor concentrates, the median annualized bleeding rate was 0.0 with fitusiran vs 21.8 in controls, and the most frequent adverse event was ALT elevations [23% vs 3%] versus none). 37003278
Pipe SW, Lissitchkov T, Georgiev P, Mangles S, Hegemann I, Trinchero A, Chowdary P, et al. Long-term safety and efficacy of fitusiran prophylaxis, and perioperative management, in people with hemophilia A or B. Blood Adv. 2025;9:1147-1158.. (Among 34 men with moderate or severe hemophilia A or B without inhibitors who had completed a phase one study of fitusiran [50 or 80 mg sc once monthly] and were then continued in an open label, long term study during which the dose regimen was changed to achieve antithrombin levels between 15% and 35%, annualized bleeding rates remained low [median <1] and rates of ALT or AST elevations above 3 times ULN decreased after the change in dose regimen [18% to 6%] and there were no instances of clinically apparent liver injury). 39642315
Young G, Kavakli K, Klamroth R, Matsushita T, Peyvandi F, Pipe SW, Rangarajan S, et al. Safety and efficacy of a fitusiran antithrombin-based dose regimen in people with hemophilia A or B: the ATLAS-OLE study. Blood. 2025;145:2966-2977.. (Analysis of an open label study of fitusiran in 286 males aged 12 and above with severe hemophilia A or B, using varying doses, typically 50 mg every 2 months followed by dose adjustments to maintain antithrombin levels of 15% to 35%, demonstrated an annualized bleeding rate of 3.7, with an overall adverse event rate of 83%, serious adverse events in 14.3%; ALT or AST elevations above 3 times ULN due to therapy occurred in only 5 patients [2%], none with jaundice, all resolving rapidly, and only 1 requiring drug discontinuation). 40053895
Lee A. Fitusiran: first approval. Drugs. 2025 Jun 28. Epub ahead of print.. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of fitusiran shortly after its approval in the United States mentions that “hepatic injury” occurred in 8% of patients which occasional led to early discontinuation and accounted for at least one serious adverse event, and that 17% of patients developed “gallbladder events” that led to cholecystectomy in 4%). 40579682
Fitusiran (Qfitlia) for hemophilia A and B. Med Lett Drugs Ther. 2025;67(1732):110-111.. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of fitusiran shortly after its approval states that “hepatotoxicity can occur; liver tests should be evaluated before starting treatment, monthly for at least the first 6 months after starting treatment and after dose increases, and periodically thereafter”). 40600947

## OTHER REFERENCE LINKS

1. Recent References on Fitusiran: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=fitusiran+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Fitusiran: from ClinicalTrials.gov (https://www.clinicaltrials.gov/ct2/results?term=fitusiran)